# Tovorafenib

## OVERVIEW

### Introduction

Tovorafenib is a small molecule inhibitor of RAF kinase and is used to treat children with relapsed or refractory low-grade glioma harboring a BRAF fusion or rearrangement. Tovorafenib is associated with a high rate of mild-to-moderate elevations in serum aminotransferase and bilirubin levels during therapy but has not been linked to episodes of clinically apparent liver injury with jaundice.

### Background

Tovorafenib (toh voh ra feh’ nib) is a small molecule inhibitor of type II BRAF kinase and is used to treat children with relapsed or refractory low-grade glioma harboring a BRAF fusion or rearrangement. Low grade glioma is the most common cause of brain tumors in children. While they are often referred to as “benign” and are typically slow growing, if not amenable to surgical resection, they are a cause of significant morbidity with neurologic symptoms and disability (vision loss, endocrine dysfunction, motor impairment) and potential mortality. The sporadic low-grade gliomas often have alterations in type II BRAF that lead to activation of the MAP kinase pathway and progressive growth. Tovorafenib inhibits both wild type and altered forms of BRAF, and in open-label studies demonstrated evidence of tumor response in half of children with incomplete surgical resection or with tumors not amenable to surgery. Based upon these results, tovorafenib was given accelerated approval in the United States in 2024 as therapy for children with relapsed or refractory low-grade glioma who harbor a genetic variant of BRAF kinase. Tovorafenib is available in tablets of 100 mg and as an oral suspension of 25 mg/mL under the brand name Ojemda. The recommended dose regimen ranges from 125 to 600 mg (based upon body surface area) given orally once weekly. Side effects are common and can be severe. Common adverse events include rash, change in hair color, fatigue, viral infections, nausea, vomiting, constipation, headache, hemorrhage, fever, dry skin, dermatitis acneiform and upper respiratory infections. Laboratory abnormalities can include increases in serum creatine phosphokinase (CPK), ALT and AST and decreases in neutrophils, lymphocytes, hemoglobin, albumin, phosphate, potassium and sodium. Less frequent but potentially severe adverse events include major hemorrhage, severe skin toxicity, photosensitivity, hepatotoxicity, growth retardation, increased tumor growth, and embryo-fetal toxicity.

### Hepatotoxicity

In the prelicensure trials of tovorafenib, a safety cohort of 172 participants, at least half of whom were treated for more than 1 year, was used to evaluate rates of adverse events. Severe adverse events arose in 45% of patients, most frequently rash (12%), viral infections (7%), fatigue (4%), fever (4%), and hemorrhage (5%). A single fatal adverse event was due to tumor hemorrhage. ALT elevations arose in 50%, AST 83%, CPK 83%, and bilirubin 22%. ALT levels rose to above 5 times ULN in 5%, and AST in 2%. The median time to onset of aminotransferase elevations was 14 days (range 3 to 280 days) and required dose interruptions in 5%, but rarely required drug discontinuation. There were no enzyme elevations with jaundice or symptoms and no life-threatening or fatal instances of liver injury. Since approval and clinical availability of tovorafenib, there have been no published case reports of clinically apparent liver injury with jaundice, but clinical experience with its use has been limited.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The causes of serum enzyme elevations or liver injury from tovorafenib therapy are possibly due to direct toxicity of the BRAF and MAPK pathway inhibition. Tovorafenib is metabolized in the liver largely via CYP 2C8 and partially by CYP 3A4 and is susceptible to drug-drug interactions with inducers or inhibitors of CYP 2C8. Tovorafenib is a CYP 3A inducer that can alter the metabolism of CYP 3A substrates.

### Outcome and Management

The product label for tovorafenib recommends monitoring of liver tests before therapy, one month after starting and every three months thereafter and as clinically indicated. Serum aminotransferase elevations above 5 times the upper limit of normal or any elevations accompanied by jaundice or symptoms should lead to discontinuation until levels fall to less than twice ULN. There is little information on cross reactivity in risk for adverse events, hypersensitivity, or hepatic injury between tovorafenib and other BRAF inhibitors such as dabrafenib, vemurafenib, or encorafenib.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other BRAF Inhibitors: Dabrafenib, Encorafenib, Vemurafenib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tovorafenib – Ojemda®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tovorafenib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Tovorafenib | 1096708-71-2 | C17-H12-Cl2-F3-N7-O2-S

## ANNOTATED BIBLIOGRAPHY

References updated: 8 April 2025

Abbreviations: ULN, upper limit of the normal range

Zimmerman HJ. Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase inhibitors such as tovorafenib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several tyrosine kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not tovorafenib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. Multi-Discipline Review. 2024. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2024/217700Orig1s000,%20218033Orig1s000MultidisciplineR.pdf (FDA review of the data on efficacy and safety of tovorafenib submitted by the sponsor in support of its approval for therapy of refractory or relapsed low grade glioma in children, mentions that liver test abnormalities were frequent, with elevations in ALT in 50%, AST 83%, CPK 83%, and bilirubin in 22%, but ALT levels above 5 times ULN arose in only 5% and AST in 2% and there were no cases of drug induced liver injury or concurrent rises in aminotransferase levels and bilirubin attributed to drug therapy).
Spraggs CF, Xu CF, Hunt CM. Genetic characterization to improve interpretation and clinical management of hepatotoxicity caused by tyrosine kinase inhibitors. Pharmacogenomics 2013; 14: 541-54. (Review of genetic associations of serum ALT and bilirubin elevations during therapy with tyrosine kinase inhibitors focusing on lapatinib and pazopanib; tovorafenib is not discussed). 23556451
Shah RR, Morganroth J, Shah DR. Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf 2013; 36: 491-503. (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the US as of 2013, before the availability of tovorafenib which is not discussed). 23620168
Tkacik E, Li K, Gonzalez-Del Pino G, Ha BH, Vinals J, Park E, Beyett TS, et al. Structure and RAF family kinase isoform selectivity of type II RAF inhibitors tovorafenib and naporafenib. J Biol Chem. 2023;299:104634. (RAF kinases initiate signaling through MAPK cascade to control cell growth, proliferation, and differentiation, the isoforms being ARAF, BRAF, and CRAF; tovorafenib is a type II BRAF inhibitor with potent activity against CRAF but not ARAF). 36963492
Kilburn LB, Khuong-Quang DA, Hansford JR, Landi D, van der Lugt J, Leary SES, Driever PH, et al. The type II RAF inhibitor tovorafenib in relapsed/refractory pediatric low-grade glioma: the phase 2 FIREFLY-1 trial. Nat Med. 2024;30:207-217. (Arm 1 of an ongoing trial of tovorafenib included 77 patients with BRAF-altered relapsed or refractory pediatric low-grade glioma in which the overall response rate was 67% with median duration of 16.6 months and adverse events included CPK elevations in 58%, AST 34% and ALT 21% [5% above 5 times ULN]). 37978284
van Tilburg CM, Kilburn LB, Perreault S, Schmidt R, Azizi AA, Cruz-Martínez O, Zápotocký M, et al. LOGGIC/FIREFLY-2: a phase 3, randomized trial of tovorafenib vs. chemotherapy in pediatric and young adult patients with newly diagnosed low-grade glioma harboring an activating RAF alteration. BMC Cancer. 2024;24:147. (Trial design of an ongoing phase 3, randomized controlled trial of tovorafenib vs standard chemotherapy in children and young adults with relapsed or refractory low-grade glioma harboring BRAF mutations or fusions). 38291372
Tovorafenib (Ojemda) for pediatric low-grade glioma. Med Lett Drugs Ther. 2024;66: e97-e98. (Concise review of the mechanism of action, clinical efficacy, current indications, safety, and costs of tovorafenib in pediatric low-grade gliomas with BRAF mutation, fusion, or rearrangement, mentions that “liver function tests should be monitored before and during treatment”). 38905536
Dhillon S. Tovorafenib: first approval. Drugs. 2024;84:985-993. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of tovorafenib shortly after its approval as therapy of pediatric low-grade gliomas in the US mentions that it has an “acceptable tolerability profile” and that ALT elevations above 5 times ULN arose in 5% of patients). 38967715
Singh S, Bradford D, Chatterjee S, Li X, Aungst SL, Skinner AM, Miller CP, et al. FDA approval summary: tovorafenib for relapsed or refractory BRAF-altered pediatric low-grade glioma. Clin Cancer Res. 2025 Jan 14. Epub ahead of print. (Summary of the data on efficacy and safety that supported the FDA’s accelerated approval of tovorafenib as therapy of relapsed or refractory, pediatric low-grade glioma with BRAF alterations, states that the safety cohort consisted of 172 patients, half of whom received tovorafenib for at least one year, in whom serious adverse events occurred in 45%, drug interruptions in 57%, and discontinuations in 7%; no mention of ALT elevations or hepatotoxicity). 39808502

## OTHER REFERENCE LINKS

1. Recent References on Tovorafenib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Tovorafenib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Tovorafenib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tovorafenib)